# Pyrazinamide

## OVERVIEW

### Introduction

Pyrazinamide is a first line antituberculosis medication, but is used only in combination with other antituberculosis medications such as isoniazid or rifampin. Pyrazinamide is associated with transient and asymptomatic elevations in serum aminotransferase levels and is a well known cause of clinically apparent, acute liver injury that can be severe and even fatal.

### Background

Pyrazinamide (pir" a zin' a mide) is a synthetic pyrazine analogue of nicotinamide that has potent activity against mycobacterium tuberculosis. Its mechanism of action is unknown, but it appears to be both bactericidal and bacteriostatic. Pyrazinamide is considered an adjunctive therapy of tuberculosis and is always used in combination with another antimycobacterial agent such as isoniazid or rifampin. Pyrazinamide was developed and introduced into clinical use in 1956 and continues to be commonly used in therapy of active tuberculosis, but not for latent tuberculosis. It is available as tablets of 500 mg in several generic forms. A fixed combination of pyrazinamide (300 mg) with isoniazid (50 mg) and rifampin (120 mg) is also available under the brand name of Rifater. The recommended dosage of pyrazinamide is 15 to 30 mg/kg daily in one or more doses, but not in excess of 2 grams daily. Pyrazinamide can also be given in a twice weekly regimen of 50 to 70 mg/kg per dose allowing for observed administration and better compliance. Typically, pyrazinamide and ethambutol are given only for the first two months of 3- or 4-drug combination therapy of active tuberculosis, with continuation of isoniazid and rifampin for at least six months. Common side effects of pyrazinamide are fatigue, anorexia, gastrointestinal upset, arthralgias, rash and photosensitivity.

The management of tuberculosis is challenging and should be under the direction of physicians with expertise in tuberculosis therapy and management of its side effects. Optimal regimens of therapy for tuberculosis are complex and change frequently. Regularly updated recommendations on use of drugs for tuberculosis, including indications, contraindications, warnings, dosages and monitoring recommendations are available at the Centers for Disease Control and Prevention website: http://www.cdc.gov/tb/publications/guidelines/Treatment.htm.

### Hepatotoxicity

Combination therapy for tuberculosis using pyrazinamide is commonly associated with transient and asymptomatic elevations in the serum aminotransferase levels. These elevations are usually less than five times the upper limit of the normal range. Because pyrazinamide is used only in combination with other antituberculosis medications, its contributions to serum enzyme elevations is not completely clear, but it is frequently incriminated in transient serum enzyme elevations. Clinically apparent liver disease with symptoms and jaundice also occur with pyrazinamide therapy and it is often considered the culprit in causing liver injury in the face of double or triple antituberculosis therapy (Case 1). Indeed, the use of a short, 2 month course of combination therapy with rifampin and pyrazinamide for latent tuberculosis was abandoned because of the frequency of severe liver injury with this regimen that was occasionally fatal (Case 2). The onset of injury due to pyrazinamide is generally after 4 to 8 weeks and occasionally becomes apparent only after the pyrazinamide is stopped. The pattern of liver enzyme elevations is typically hepatocellular and the clinical syndrome resembles acute viral hepatitis, much like isoniazid hepatotoxicity. Features of hypersensitivity (rash, fever and eosinophilia) are uncommon as are autoantibody formation. Liver biopsy demonstrates changes typical of acute hepatitis with portal and lobular inflammation, hepatocellular necrosis and variable degrees of cholestasis.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatic injury by pyrazinamide is not known, but the drug is extensively metabolized by the liver and injury may be caused by a metabolic intermediate. Hepatotoxicity from pyrazinamide appears to be more frequent with higher doses, suggesting a direct toxic effect, at least in part.

### Outcome and Management

The appearance of liver injury with symptoms and serum aminotransferase levels above 3 times the ULN or any elevation in aminotransferase levels above 5 times the ULN should prompt withdrawal of pyrazinamide. Many cases of pyrazinamide hepatotoxicity are severe and prolonged, and fatal instances have occurred. Pyrazinamide has not been linked to chronic hepatitis or vanishing bile duct syndrome. There is no cross reactivity of the hepatic injury with other currently available antituberculosis agents.

After drug induced liver injury from combination antituberculosis therapy, reinitiation of therapy, if necessary, can be achieved best by sequential and incremental introduction of the agents (generally isoniazid and rifampicin), but that restarting several drugs at the standard dosage should be avoided particularly starting with pyrazinamide in full doses.

[First line medications used in the therapy of tuberculosis in the United States include isoniazid, pyrazinamide, ethambutol and the rifamycins including rifampin, rifabutin and rifapentine. Second line medications include streptomycin, capreomycin, cycloserine, ethionamide, bedaquiline, pretomanid, fluoroquinolones such as levofloxacin, and moxifloxacin, aminoglycosides such as amikacin, and para-aminosalicylic acid (PAS).]

Drug Class: Antituberculosis Agents

Other Drugs in the Class: Bedaquiline, Capreomycin, Cycloserine, Ethambutol, Ethionamide, Isoniazid, Pretomanid, Rifabutin, Rifampin, Rifapentine, Streptomycin

## CASE REPORTS

### Case 1. Acute liver failure due to combination antituberculosis therapy.(1)

A 60 year old woman with pulmonary tuberculosis was treated with isoniazid (300 mg daily), rifampin (600 mg daily) and pyrazinamide (1.5 gram daily) and improved rapidly, but was found to have jaundice with bilirubin 3.5 mg/dL, AST 538 U/L and alkaline phosphatase 148 U/L six weeks after starting therapy (Table). Her liver tests were reported to be normal before treatment. She had no history of liver disease, alcohol abuse, or risk factors for viral hepatitis. Isoniazid and rifampin were stopped but pyrazinamide continued. One week later, she was admitted to a local hospital for worsening hepatic function. She was mildly encephalopathic and the prothrombin time was prolonged. She was transferred to a liver transplant center. She was in stage 3 hepatic coma and required artificial ventilation. Pyrazinamide was stopped and ofloxacin, ethambutol and streptomycin started. Blood tests for hepatitis A, B and C were negative. She underwent successful liver transplantation 5 days after transfer and 3 weeks after onset of symptoms. She recovered uneventfully and was discharged 16 days after transplant on cyclosporine and prednisone. She was maintained on ethambutol, streptomycin and ofloxacin for tuberculosis, and sputum cultures remained negative.

#### Key Points

Medication: | Isoniazid, rifampin, pyrazinamide
Pattern: | Hepatocellular (R=10.1)
Severity: | 5+ (acute liver failure requiring liver transplantation)
Latency: | 6 weeks
Recovery: | No
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Protime* (Seconds) | Bilirubin* (mg/dL) | Other
Pre | | Normal | Normal | Normal
Isoniazid, rifampin and pyrazinamide started for active tuberculosis
6 weeks | -7 days | 548 | | 3.5
7 weeks | 0 | 1640 | 22.4 | 22.4 | Admission
| 3 days | 1100 | 34.0 | 32.0 | Transfer
8 weeks | 7 days | 350 | 41.0 | 21.0
| | Emergency liver transplantation
3 months | 1 month | 30 | 11.0 | 5.0 | Discharge
Normal Values | | <40 | <14 | <1.2

* Some values estimated from Figure 2.

#### Comment

This case demonstrates an acute viral hepatitis-like presentation of drug induced liver injury. While the case represents “definite” drug induced liver disease, it is impossible to be definitive about which agent was responsible. Isoniazid is a likely culprit, but pyrazinamide and (to a lesser degree) rifampin are also capable of causing acute severe liver injury, and continuing pyrazinamide in the face of an acute hepatitis-like syndrome was not advisable. Despite stopping isoniazid and rifampin therapy promptly, the patient progressed to hepatic failure and required liver transplantation within 3 weeks of initial presentation. Risk factors for antituberculosis therapy associated hepatitis included age and combination therapy. Risk factors for severe outcome were age and sex.

### Case 2. Acute liver failure complicating two month course of rifampin and pyrazinamide.(2)

A 68 year old man with a history of a positive tuberculin test requested antituberculosis therapy so as to obviate the need for annual chest X-rays required by his employer. He had a history of alcoholic liver disease, but had stopped drinking 5 years previously. He also had gout, hypertension and type 2 diabetes for which he took aspirin, colchicine, ibuprofen, lisinopril and metformin on a chronic basis. He was started on rifampin (600 mg daily) and pyrazinamide (2 grams daily) and monitored monthly. He tolerated therapy without symptoms and liver tests were normal at baseline and at one month (Table). Immediately after stopping therapy, however, he began to feel ill and presented to the emergency room with jaundice, lethargy and confusion. On examination, he was icteric and had asterixis. Laboratory tests showed marked elevations in serum aminotransferase levels and bilirubin of 16.7 mg/dL. The prothrombin time was prolonged [INR 6.0]; and there were elevations in serum creatinine (5.4 mg/dL), ammonia (181 μmol/L: normal <35) and lactate (13.2 mmol/L, normal <2.2). Abdominal ultrasound showed ascites, but no evidence of biliary obstruction. He was given supportive care but developed worsening coma, respiratory and renal failure and died 3 days after admission.

#### Key Points

Medication: | Pyrazinamide, rifampin
Pattern: | Hepatocellular (R=10)
Severity: | 5+ (death)
Latency: | 2 months
Recovery: | None
Other medications: | Aspirin, colchicine, ibuprofen, lisinopril, metformin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 48 | 66 | 0.5 | INR=1.0
0 | | Pyrazinamide and rifampin started
2 weeks | | 31 | 63 | 0.5
8 weeks | 0 | Pyrazinamide and rifampin stopped: asymptomatic
| 3 days | 620 | 175 | 16.7 | INR=6.0
9 weeks | 6 days | 1930 | 207 | 19.2 | INR=10.1
| 8 days | Death from multiorgan failure
Normal Values | | <45 | <130 | <1.2

#### Comment

The patient developed an abrupt onset of acute liver failure a few days after stopping an 8 week course of rifampin and pyrazinamide for latent tuberculosis. This combination is highly effective for latent tuberculosis, but has been associated with an unacceptably high rate of liver injury and cases of acute liver failure, for which reasons it is no longer recommended. Whether the injury was due to pyrazinamide or rifampin was unclear; there is likely an interaction that promotes the risk of injury. The risk of liver injury increases with age not just with isoniazid, but also with other antituberculosis medications and combinations. History of alcohol abuse and alcoholic liver injury are believed to also be risk factors for antituberculosis medication hepatotoxicity, but it has not been clearly defined. Because pyrazinamide inhibits the renal excretion of urates, it should be used with caution in patients with gout. This report does not mention testing for viral hepatitis or autopsy results; but the clinical history and course are entirely compatible with drug induced liver injury from antituberculosis medications.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pyrazinamide – Generic, Tebrazid®

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=pyrazinamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pyrazinamide | 98-96-4 | C5-H5-N3-O

## CITED REFERENCES

1 Farrell FJ, Keeffe EB, Man KM, Imperial JC, Esquivel CO. (1994). Treatment of hepatic failure secondary to isoniazid hepatitis with liver transplantation. Dig Dis Sci.
2 Medinger A. (2002). Death associated with rifampin and pyrazinamide 2-month treatment of latent Mycobacterium tuberculosis. Chest.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 December 2020

Abbreviations: DRESS, drug rash with eosinophilia and systemic symptoms; HIV, human immunodeficiency virus; MAC, Mycobacterium avium complex; PAS, para-aminosalicylic acid.

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications including pyrazinamide published in 1999).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs).
Gumbo T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1067-86. (Textbook of pharmacology and therapeutics).
Aquinas SM. (1964). Reactions to antituberculosis drugs among Chinese in Hong Kong. Tubercle. (Among 389 patients treated with pyrazinamide and ethionamide for tuberculosis, side effects requiring discontinuation of therapy occurred in 4 [1%], including 3 with jaundice [all attributed to pyrazinamide], one of whom died).
Ramakrishnan CV, Janardhanam B, Krishnamurthy DV, Stott H, Subbammal S, Tripathy SP. (1968). Toxicity of pyrazinamide, administered once weekly in high dosage, in tuberculous patients. Bull World Health Organ. (Pilot study of once weekly pyrazinamide [70 mg/kg] with isoniazid and streptomycin for 12 months in 19 patients with tuberculosis, found minor elevations in ALT and AST during therapy usually in first two weeks [peak ALT 63 U/L], but no patient developed clinically apparent hepatitis).
Simpson AJ, Mirza AM, Martin JF, O'Brien TF. (1970). Hepatitis secondary to pyrazinamide toxicity: accompaniments of transient hypolipoproteinemia, acanthocytosis, and changes in stomach and small bowel. South Med J. (34 year old developed jaundice 6 months after starting pyrazinamide and streptomycin for tuberculosis [bilirubin 26.4 mg/dL, AST 318 U/L, Alk P normal, protime 22.9 sec, cholesterol 68 mg/dL and acanthocytosis], resolving slowly over next 3 months).
Rossouw JE, Saunders SJ. (1975). Hepatic complications of antituberculous therapy. Q J Med. (Retrospective review identified 38 cases of hepatitis [~0.32%] due to antituberculosis therapy [Cape Town, SA], 16 due to PAS, 12 to PAS with isoniazid, 3 isoniazid alone, 1 each of others including ethambutol; rash and fever typical of PAS reactions, most within 90 days; 33 with jaundice).
Hong Kong Tuberculosis Treatment services/British Medical Research Council. (1976). Adverse reactions to short-course regimens containing streptomycin, isoniazid, pyrazinamide and rifampicin in Hong Kong. Tubercle. (Summary of 3 clinical trials of antituberculosis therapy [isoniazid, rifampin and pyrazinamide] from Hong Kong; hepatotoxicity in 6-11% of subjects, jaundice in 0.7%, no deaths, pyrazinamide implicated most frequently).
Girling DJ. (1978). The hepatic toxicity of antituberculosis regimens containing isoniazid, rifampicin and pyrazinamide. Tubercle. (History and review of hepatotoxicity of first line antituberculosis medications).
Ellard GA, Mitchison DA, Girling DJ, Nunn AJ, Fox W. (1978). The hepatic toxicity of isoniazid among rapid and slow acetylators of the drug. Am Rev Respir Dis. (Among 145 patients with active tuberculosis treated with isoniazid, pyrazinamide and streptomycin, there was no correlation of acetylator phenotype and ALT elevations; postulate that rapid acetylators also rapidly metabolize and excrete monoacetylhydrazine the first product of acetylation and purported hepatotoxin).
Singapore Tuberculosis Service/British Medical Research Council. (1979). Clinical trial of six-month and four-month regimens of chemotherapy in the treatment of pulmonary tuberculosis. Am Rev Respir Dis. (Among 397 patients with active tuberculosis treated with combination regimens, 11 [3%] developed hepatitis with jaundice, all in first 3 months, all recovered, all on rifampin, 10 on pyrazinamide and 2 on isoniazid).
Addington WW. (1979). The side effects and interactions of antituberculosis drugs. Chest. (Review of side effects of antituberculosis medications states that isoniazid, rifampin and pyrazinamide are major causes of hepatotoxicity, but ethambutol rarely causes liver injury).
Zierski M, Bek E. (1980). Side-effects of drug regimens used in short-course chemotherapy for pulmonary tuberculosis. A controlled clinical study. Tubercle. (Among 530 patients treated with 5 regimens for active tuberculosis and monitored monthly, 9% developed hepatic injury but usually without symptoms, ALT >250 U/L in 6 [1.1%], bilirubin rise in 7 [1.3%]).
Pretet S, Perdrizet S. (1980). Rev Fr Mal Respir. (Review of large trials worldwide of antituberculosis therapy for rate of adverse drug reactions; overall hepatotoxicity occurred in 2.2% of 4,025 subjects treated with pyrazinamide containing regimens vs 0.5% of 2,368 without).
British Thoracic Association. (1981). A controlled trial of six month chemotherapy in pulmonary tuberculosis. First report: results during chemotherapy. Br J Dis Chest. (Comparison of 3 regimens of therapy in 611 patients with active tuberculosis; 6 vs 9 months duration, with and without pyrazinamide; hepatitis occurred in 4% of patients with all 3 regimens and 8 patients [1.3%] had jaundice; hepatotoxicity occurred in 3% of men and 6% of women).
Danan G, Pessayre D, Larrey D, Benhamou JP. (1981). Pyrazinamide fulminant hepatitis: an old hepatotoxin strikes again. Lancet. (37 year old man with active tuberculosis developed elevated ALT after 8 months of therapy; isoniazid was stopped and pyrazinamide continued, and patient developed acute liver failure [ALT 30 times ULN, Alk P twice normal] and died).
Pilheu JA, De Salvo MC, Koch O. (1981). Liver alterations in antituberculosis regimens containing pyrazinamide. Chest. (Prospective study of 59 alcoholic men with active tuberculosis treated with four drugs including isoniazid, rifampin, streptomycin and either pyrazinamide or ethambutol with monthly monitoring and liver biopsy before and after 2 months of therapy found no evidence of increased hepatotoxicity comparing pyrazinamide and ethambutol groups).
Hong Kong Chest Service/British Medical Research Council. (1982). Controlled trial of 4 three-times-weekly regimens and a daily regimen all given for 6 months for pulmonary tuberculosis. Second report: the results up to 24 months. Tubercle. (Among 833 patients with active tuberculosis randomized to one of 5 regimens, hepatotoxicity occurred in 2.7% and only 3 [0.4%] were jaundiced; most were able to finish therapy).
Girling DJ. (1982). Adverse effects of antituberculosis drugs. Drugs. (Review of side effects of drugs for tuberculosis; isoniazid alone leads to hepatitis in 0.5% of patients increasing with age from 0.3% <35, 0.8% >55 years, higher rates when it is combined with other agents; pyrazinamide found to be hepatotoxic in high doses [40 mg/kg/day], but not with lower doses – “So far there has been no report of a high incidence of hepatotoxicity with the modern pyrazinamide regimens studied”).
Cohen CD, Sayed AR, Kirsch RE. (1983). Hepatic complications of antituberculosis therapy revisited. S Afr Med J. (Among 5565 patients treated for tuberculosis in Cape Town SA, 17 [0.3%] developed hepatitis, rate similar to that when PAS was used. Among 28 cases seen, 13 attributed to isoniazid, 16 pyrazinamide and 8 rifampin, mostly in combination; 2 deaths).
Fiala W, Häcki MA, Brändli O. (1983). Schweiz Med Wochenschr. (Controlled trial comparing pyrazinamide [n=52: <2 g/day] vs ethambutol [n=61] for first 2-3 months with isoniazid and rifampin for 9 months to treat active tuberculosis; hepatitis occurred in 5 on pyrazinamide and 2 on ethambutol, all in first month, 3 symptomatic, no deaths, most were >70 years of age).
Cataldi Amatriain RM, Rossi Case E. (1984). Rev Esp Enferm Apar Dig. (Pyrazinamide is similar in structure to isoniazid, initially found to be hepatotoxic, but then lower doses appeared to be safe and combination therapy allowed for shorter courses; among 34 patients treated, Alk P was 2-3 times ULN in 5 and ALT 2-3 times ULN in 4, all arising during first 30 days, all asymptomatic and resolving once pyrazinamide stopped).
Cataldi Amatriain RM, Rossi Case E. (1984). Rev Esp Enferm Apar Dig.
Parthasarathy R, Sarma GR, Janardhanam B, Ramachandran P, Santha T, Sivasubramanian S, Somasundaram PR, Tripathy SP. (1986). Hepatic toxicity in South Indian patients during treatment of tuberculosis with short-course regimens containing isoniazid, rifampicin and pyrazinamide. Tubercle. (Hepatitis occurred in 10% of patients with spinal tuberculosis, 16-39% of children with meningitis and 2-8% with pulmonary disease treated with rifampin and isoniazid, arising 1-6 months after starting therapy, more commonly in slow acetylators).
(1986). Tuberculosis Research Centre, Madras, and National Tuberculosis Institute, Bangalore. A controlled clinical trial of 3- and 5-month regimens in the treatment of sputum-positive pulmonary tuberculosis in South India. Am Rev Respir Dis. (Analysis of 3 regimens for therapy of active tuberculosis in 908 patients; jaundice occurred in 6-8% of subjects on rifampin, but only 1% of subjects on nonrifampin regimens [isoniazid, pyrazinamide and streptomycin], but no mention of rates of death or clinically apparent hepatitis).
Swamy R, Acharyulu GS, Duraipandian M, Jawahar MS, Ramachandran R, Sarma GR. (1987). Liver function tests during treatment of tuberculosis with short-course regimens containing isoniazid, rifampicin & pyrazinamide. Indian J Med Res.
Donald PR, Schoeman JF, O'Kennedy A. (1987). Hepatic toxicity during chemotherapy for severe tuberculosis meningitis. Am J Dis Child. (Among 33 children with tuberculous meningitis treated with 3-4 agents, liver test abnormalities were common [85%], but usually mild and transient; only one child developed jaundice who was also IgM anti-HAV positive and who later tolerated therapy without recurrence).
van Aalderen WMC, Knoester H, Knol K. (1987). Fulminant hepatitis during treatment with rifampicin, pyrazinamide and ethambutol. Eur J Pediatr. (10 year old girl developed nausea and ALT elevations 2 weeks after starting isoniazid, rifampin, pyrazinamide and ethambutol, resolving with stopping all drugs, but severe recurrence with fever, rash and fatal acute liver failure 6 weeks after adding pyrazinamide back to rifampin, ethambutol and kanamycin).
Roden S, Lagneau M, Homasson JP. (1990). Rev Pneumol Clin. (68 year old woman developed jaundice 3.5 months after starting antituberculosis therapy with rifampin, pyrazinamide and ethambutol [bilirubin 9.6 mg/dL, ALT 1100 U/L, Alk P 185 U/L, prothrombin index 45%], with progressive hepatic failure leading to liver transplantation, by followed by death 10 days postoperatively).
Kshirsagar NA, Karande SC, Potkar CN. (1992). A prospective survey of drug induced hepatotoxicity in a large hospital. Indian J Gastroenterol. (Among 11 cases of drug induced liver disease, 9 were due to antituberculosis medications, usually combinations of isoniazid, rifampin and pyrazinamide, 2 deaths).
Padmini R, Srinivasan S, Nalini P, Mahadevan S. (1993). Short course chemotherapy for tuberculosis in children. J Trop Pediatr. (Among 83 children [<12 years] treated for tuberculosis [using 2-4 agents, including pyrazinamide] in India between 1988-91, 4 developed hepatitis with jaundice [bilirubin 2.0-4.5 mg/dL, ALT >4 times ULN], but all resolved with decrease in dose of isoniazid and rifampin).
Altman C, Biour M, Grangé JD. (1993). Presse Med. (Analysis of 199 cases of hepatotoxicity from antituberculosis medications from literature [n=169] and French pharmacovigilance system [n=30]; overall mortality rate was 23%, rifampin cases had short latency [average 2 weeks] compared to isoniazid [11 weeks] and pyrazinamide [7 weeks] cases; there was no association with alcohol, but some with higher doses, particularly isoniazid).
Robson SC, Pillans P, Willcox PA. (1993). Treatment of tuberculosis in patients with pre-existing liver disease or following hepatotoxic drug reactions. S Afr Med J. (Review of problems of treating tuberculosis in patients with preexisting liver disease, recommended avoiding pyrazinamide).
van der Kooi K, Mottet JJ, Regamey C. (1994). Isoniazid is not always the cause of hepatitis during treatment of tuberculosis. Clin Infect Dis. (46 year old man developed hepatitis [ALT 900 U/L] 2 weeks after starting isoniazid, rifampin, pyrazinamide and ethambutol, with positive challenge with pyrazinamide and not by isoniazid; no mention of fever, rash or bilirubin levels).
Türktaş H, Unsal M, Tülek N, Orüç O. (1994). Hepatotoxicity of antituberculosis therapy (rifampicin, isoniazid and pyrazinamide) or viral hepatitis. Tuber Lung Dis. (Among 705 Turkish adults with tuberculosis, 57 [8%] developed hepatitis with jaundice during therapy with isoniazid and rifampin; serologic testing showed hepatitis A in none, B in 6 and C in 4).
Farrell FJ, Keeffe EB, Man KM, Imperial JC, Esquivel CO. (1994). Treatment of hepatic failure secondary to isoniazid hepatitis with liver transplantation. Dig Dis Sci. (Two cases of acute liver failure attributed to isoniazid: 49 year old man on isoniazid for latent tuberculosis for 4 months developed jaundice [bilirubin 16.1 mg/dL, AST 2882 U/L]; and 60 year old woman developed jaundice 6 weeks after starting isoniazid, rifampin, and pyrazinamide for active tuberculosis [bilirubin 3.5 mg/dL, AST 548 U/L], both progressing to hepatic failure and undergoing successful liver transplantation).
Horn DL, Hewlett D, Alfalla C, Peterson S, Opal SM. (1994). Limited tolerance of ofloxacin and pyrazinamide prophylaxis against tuberculosis. N Engl J Med. (Among 16 contacts of a case of multidrug resistant tuberculosis treated with pyrazinamide and ofloxacin, side effects were common; 4 had hepatitis [ALT 491-1776 U/L], only 2 completed therapy).
Singh J, Arora A, Garg PK, Thakur VS, Pande JN, Tandon RK. (1995). Antituberculosis treatment-induced hepatotoxicity: role of predictive factors. Postgrad Med J. (Case control study of 60 patients with liver injury due to antituberculosis medications and 60 controls from India identified lower body mass index and use of pyrazinamide, but not age, sex, or acetylator status as risk factors).
Mitchell I, Wendon J, Fitt S, Williams R. (1995). Anti-tuberculous therapy and acute liver failure. Lancet. (Four cases of acute liver failure in patients on isoniazid, rifampin and pyrazinamide; 3 women and 1 man, ages 31-61 years, jaundice after 1-6 weeks, two requiring liver transplantation, one recovered, one died; unclear which agent was responsible).
Noble A. (1995). Antituberculous therapy and acute liver failure. Lancet. (Letter in response to Mitchell [1995] suggesting that patients be warned to stop the medication if they develop symptoms of liver injury).
Janes SL, Behrens J. (1995). Antituberculous therapy and acute liver failure. Lancet. (Letter in response to Mitchell [1995] reporting a 45 year old man who developed hepatitis 5 weeks after starting isoniazid and rifampin [bilirubin 3.3 mg/dL, ALT 1884 U/L], who recovered rapidly with prompt stopping of both).
Ozick LA, Jacob L, Comer GM, Lee TP, Ben-Zvi J, Donelson SS, Felton CP. (1995). Hepatotoxicity from isoniazid and rifampin in inner-city AIDS patients. Am J Gastroenterol. (Among 70 AIDS patients with active tuberculosis receiving isoniazid, rifampin and pyrazinamide for 2 months, ALT or AST levels >200 U/L occurred in 8 [11%] with peak bilirubin values 0.6-2.9 mg/dL).
Corbella X, Vadillo M, Cabellos C, Fernandez-Viladrich P, Rufi G. (1995). Hypersensitivity hepatitis due to pyrazinamide. Scand J Infect Dis. (59 year old woman developed abdominal pain and fever 1 month after starting isoniazid, rifampin, ethambutol and pyrazinamide [bilirubin 7.9 mg/dL, ALT 1260 U/L, 14% eosinophils], with positive rechallenge to pyrazinamide [ALT 3240 U/L], later tolerating ethambutol, rifampin and streptomycin).
Moitinho E, Salmerón JM, Mas A, Bruguera M, Rodés J. (1996). Gastroenterol Hepatol. (Among 27 cases of severe acute hepatitis seen in 1994 in Barcelona, 5 cases were due to antituberculosis medications, 1 woman and 4 men, ages 25 to 62 years, 2 with HBsAg, 1 with anti-HCV, arising after 11-62 days [peak bilirubin 8-41 mg/dL; ALT 450-2320 U/L, Alk P 1.5-2 times ULN], 3 died, one required liver transplant, one recovered spontaneously).
de Souza AF. (1996). de Oliveira e Silva A, Baldi J, de Souza TN, Rizzo PM. Arq Gastroenterol.
Pande JN, Singh SP, Khilnani GC, Khilnani S, Tandom RK. (1996). Risk factors for hepatotoxicity from antituberculosis drugs: a case-control study. Thorax. (Comparison of 86 patients with hepatitis due to antituberculosis therapy to 406 patients who tolerated therapy; risk factors for liver injury were older age, history of high alcohol intake [20% vs 5%], more extensive disease [14% vs 3.5%], slow acetylator status [83% vs 64%] and use of pyrazinamide [63% vs 25%]).
al Sarraf KA, Michielsen PP, Hauben EI, Lefebure A, Ramon AM, Van Marck EA, Pelckmans PA. (1996). Hepatotoxicity after a short course of low-dose pyrazinamide. Acta Gastroenterol Belg. (32 year old man with tuberculosis developed ALT elevations [50 times ULN] 10 weeks after starting isoniazid, resolving promptly on stopping, but rising again within 3 weeks of starting pyrazinamide and rifampin with worsening despite stopping both agents [peak bilirubin 1.2 mg/dL, ALT 1455 U/L, Alk P 107 U/L 10 weeks after withdrawal], resolving slowly and incompletely).
Ormerod LP, Horsfield N. (1996). Frequency and type of reactions to antituberculosis drugs: observations in routine treatment. Tuber Lung Dis. (Among 1317 patients treated for active tuberculosis, hepatitis was attributed to rifampin in 1.4%, pyrazinamide in 1.2% and isoniazid in 0.3%, but none to ethambutol or streptomycin).
Ormerod LP, Skinner C, Wales J. (1996). Hepatotoxicity of antituberculosis drugs. Thorax. (Review of the problem of hepatotoxicity of antituberculosis medications and recommendations on monitoring, with biochemical monitoring recommended only for patients with preexisting liver disease; in the UK between 1965-86 there were 243 reports of liver injury due to antituberculosis therapy and 45 fatalities).
Døssing M, Wilcke JT, Askgaard DS, Nybo B. (1996). Liver injury during antituberculosis treatment: an 11-year study. Tuber Lung Dis. (Retrospective chart review on 765 Danish patients treated for tuberculosis with 3 or 4 drugs for 6-9 months; 16% had AST elevations >2 times ULN usually during first month, but only 2% required modified regimen; 7 with jaundice, no fatalities; risk factors for hepatotoxicity were female sex, age and severe tuberculosis).
Durand F, Jebrak G, Pessayre D, Fournier M, Bernuau J. (1996). Hepatotoxicity of antitubercular treatments. Rationale for monitoring liver status. Drug Saf. (Review and recommendations from France regarding monitoring of serum enzymes during therapy of tuberculosis; isoniazid may have direct hepatotoxicity because of dose relatedness and usual absence of recurrence on rechallenge; rifampin is rare cause of liver injury, usually with short latency period; pyrazinamide is clearly hepatotoxic at higher doses which should be kept to a minimum and given for 2 months only).
Knobel B, Buyanowsky G, Dan M, Zaidel L. (1997). Pyrazinamide-induced granulomatous hepatitis. J Clin Gastroenterol. (52 year old developed fever 1 month after starting pyrazinamide and streptomycin for suspected tuberculosis [bilirubin 0.6 mg/dL, ALT 136 U/L, Alk P 752 U/L] without rash or eosinophilia, resolving on stopping, biopsy showing granulomas).
Ridzon R, Meador J, Maxwell R, Higgins K, Weismuller P, Onorato IM. (1997). Asymptomatic hepatitis in persons who received alternative preventive therapy with pyrazinamide and ofloxacin. Clin Infect Dis. (Among 22 contacts of patients with multidrug resistant tuberculosis given pyrazinamide and ofloxacin, 12 developed ALT elevations after 2-25 weeks resolving in 3-5 weeks of stopping; two above 35 years in age both developed elevations [ALT 1026 and 2,990 U/L], one had eosinophilia [35%] and jaundice [bilirubin 4.1 mg/dL]).
Devoto FM, González C, Iannantuono R, Serra HA, González CD, Sáenz C. (1997). Risk factors for hepatotoxicity induced by antituberculosis drugs. Acta Physiol Pharmacol Ther Latinoam.
Hwang SJ, Wu JC, Lee CN, Yen FS, Lu CL, Lin TP, Lee SD. (1997). A prospective clinical study of isoniazid-rifampicin-pyrazinamide-induced liver injury in an area endemic for hepatitis B. J Gastroenterol Hepatol. (Prospective study of 240 patients treated for active tuberculosis with 3 drug regimen, found ALT elevations in 45% of 31 HBsAg carriers vs 26% of 209 controls; 1 death in a carrier, none in controls, but nevertheless concluded that HBsAg was not a risk factor for antituberculosis therapy associated liver injury).
Ungo JR, Jones D, Ashkin D, Hollender ES, Bernstein D, Albanese AP, Pitchenik AE. (1998). Antituberculosis drug-induced hepatotoxicity. The role of hepatitis C virus and the human immunodeficiency virus. Am J Respir Crit Care Med. (Among 134 patients with tuberculosis, 22 developed hepatotoxicity during therapy; risk factors were HCV infection [30% vs 11%] and HIV infection [27% vs 12%]; alpha interferon therapy of hepatitis C allowed for antituberculosis therapy without ALT elevations in some patients).
Rose DN. (1998). Short-course prophylaxis against tuberculosis in HIV-infected persons. A decision and cost-effectiveness analysis. Ann Intern Med. (Cost-effectiveness analysis of various regimens for treating latent tuberculosis in HIV infected persons using Markov model and various predictions of efficacy, safety, tuberculosis development and survival used rates of fatal hepatitis of 0.002% found prophylaxis to be “greatly” beneficial, including regimens using pyrazinamide and rifampin for 2 months).
Wada M, Yoshiyama T, Ogata H, Ito K, Mizutani S, Sugita H. (1999). Kekkaku.
Corrigan D, Paton J. (1999). Hepatic enzyme abnormalities in children on triple therapy for tuberculosis. Pediatr Pulmonol. (Among 43 children prospectively monitored on rifampin, isoniazid and pyrazinamide therapy, 30% had abnormal liver tests, usually in first few weeks, 2 had symptoms, 1 jaundice; all patients continued or were restarted and finished therapy).
Gordin F, Chaisson RE, Matts JP, Miller C, de Lourdes Garcia M, Hafner R, et al. (2000). Rifampin and pyrazinamide vs isoniazid for prevention of tuberculosis in HIV-infected persons: an international randomized trial. JAMA. (Controlled trial in 1583 patients with HIV infection and latent tuberculosis comparing rifampin/pyrazinamide [R/P] for 2 months to isoniazid [INH] for 12 months; active tuberculosis arose in 0.8% per year of R/P vs 1.1% of INH treated; ALT elevations >10 times ULN occurred in 1.3% of R/P vs 3.3% of INH treated; one “grade 4 hepatitis” in R/P versus 2 in INH treated).
Girotto L, Gjonovich A, Preciso G. (2000). Minerva Anestesiol. (26 year old man with pulmonary tuberculosis treated with isoniazid, rifampin, ethambutol and pyrazinamide, presented after 1 month with fever, rash and jaundice [bilirubin 8.5 mg/dL, ALT 2757 U/L], renal insufficiency and hepatic and multiorgan failure; died after 10 days; autopsy showed massive liver necrosis and acute renal tubular necrosis).
Meyers BR, Papanicolaou GA, Sheiner P, Emre S, Miller C. (2000). Tuberculosis in orthotopic liver transplant patients: increased toxicity of recommended agents; cure of disseminated infection with nonconventional regimens. Transplantation. (Toxicity was common in transplant patients treated for active tuberculosis using first line agents, but switching to second line agents was successful in treating the tuberculosis and well tolerated).
Centers for Disease Control and Prevention (CDC). (2001). Fatal and severe hepatitis associated with rifampin and pyrazinamide for the treatment of latent tuberculosis infection—New York and Georgia, 2000. MMWR Morb Mortal Wkly Rep. (First alert: initial report of 2 cases of severe hepatitis during 2 month regimen of rifampin and pyrazinamide for latent tuberculosis; 53 year old man developed ALT elevation [1734 U/L] 33 days after starting regimen followed by jaundice [bilirubin 17.8 mg/dL] and fatal hepatic failure; 59 year old woman developed symptoms at end of therapy with bilirubin 11.4 mg/dL, ALT 1735 U/L, ANA 1:640, treated with prednisone and recovered; in both cases ALT monitoring did not prevent severe hepatitis).
Centers for Disease Control and Prevention (CDC). (2001). Update: Fatal and severe liver injuries associated with rifampin and pyrazinamide for latent tuberculosis infection, and revisions in American Thoracic Society/CDC recommendations—United States, 2001. MMWR Morb Mortal Wkly Rep. (Second alert: during a 6 month period, 21 cases of liver injury were reported to the CDC associated with 2 month regimens of rifampin-pyrazinamide; 5 died of liver failure, ages 32 to 68 years, onset in 2nd month; recommended use of 9 months of isoniazid as standard regimen and need for close monitoring if rifampin-pyrazinamide is used).
de Maria A, Berardi M, Dignetti P, Ferrera L, Viassolo L, Canonica GW. (2001). Side effects of antituberculosis treatment. Thorax. (Letter arguing against use of fixed dose combination pills of pyrazinamide with isoniazid and rifampin because of the risk of hepatotoxicity and inability to adjust relative doses).
Burman WJ, Reves RR. (2001). Hepatotoxicity from rifampin plus pyrazinamide: lessons for policymakers and messages for care providers. Am J Respir Crit Care Med. (Editorial in response to MMWR report on 21 cases of severe hepatotoxicity and 5 deaths due to the combination of rifampin and pyrazinamide).
Vu D, Macdonald L. (2001). Antitubercular drugs (isoniazid, rifampin and pyrazinamide): hepatobiliary reactions. CMAJ. (Review of 420 reports to the Canadian Monitoring Program of hepatotoxicity of antituberculosis drugs identified 258 due to isoniazid alone with 7 deaths; 27 to rifampin alone with 1 death; 110 to isoniazid and rifampin with 6 deaths; 25 related to pyrazinamide alone or in combination with 3 cases of death or hepatic failure; advises biochemical monitoring for patients above the age of 35).
McCarthy M. (2001). US guidelines for treatment of latent tuberculosis revised. Lancet. (Newsletter on the modification of the US guidelines on treatment of latent tuberculosis, recommending avoidance of rifampin/pyrazinamide regimens).
Tahaoğlu K, Ataç G, Sevim T, Tärün T, Yazicioğlu O, Horzum G, Gemci I, et al. (2001). The management of anti-tuberculosis drug-induced hepatotoxicity. Int J Tuberc Lung Dis. (Description of 45 patients with hepatotoxicity from antituberculosis therapy, ages 15 to 76 years, ALT 42-897 U/L, bilirubin 0.2-7.0 mg/dL, arising in 6-102 days, with resolution in 4-58 days. No recurrence in patients with gradual reintroduction of regimen without pyrazinamide compared to 6 cases [24%] in those with abrupt reintroduction).
Wada M. (2001). Kekkaku.
Papastavros T, Dolovich LR, Holbrook A, Whitehead L, Loeb M. (2002). Adverse events associated with pyrazinamide and levofloxacin in the treatment of latent multidrug-resistant tuberculosis. CMAJ. (Among 17 persons given pyrazinamide and levofloxacin for latent tuberculosis after contact with multidrug resistant tuberculosis, adverse reactions were common, 5 [29%] had ALT elevations [peak 80-504 U/L]; all recovered after stopping).
Lee AM, Mennone JZ, Jones RC, Paul WS. (2002). Risk factors for hepatotoxicity associated with rifampin and pyrazinamide for the treatment of latent tuberculosis infection: experience from three public health tuberculosis clinics. Int J Tuberc Lung Dis. (Among 148 patients with latent tuberculosis treated with rifampin/pyrazinamide, 14 [9.4%] had ALT elevations >5 times ULN, 12 were symptomatic [8%]; risk factors were female sex and recent infection).
Medinger A. (2002). Death associated with rifampin and pyrazinamide 2-month treatment of latent Mycobacterium tuberculosis. Chest. (68 year old man developed jaundice at end of 2 month course of rifampin and pyrazinamide for latent tuberculosis [bilirubin 19.2 mg/dL, ALT 1930 U/L, Alk P 207 U/L], with liver failure and death within 3 days of presentation: Case 2).
Castro KG, Jereb JA, Koppaka VR, Cohn DL. (2003). Fatal liver injury associated with rifampin-pyrazinamide treatment of latent tuberculosis infection. Chest. (Letter in response to Medinger [2002] on need to report cases of hepatotoxicity of antituberculosis therapy to the CDC).
Centers for Disease Control and Prevention (CDC). (2002). Update: Fatal and severe liver injuries associated with rifampin and pyrazinamide treatment for latent tuberculosis infection. MMWR Morb Mortal Wkly Rep. (Third alert: 40 cases of severe hepatotoxicity [8 fatal] associated with rifampin/pyrazinamide therapy of latent tuberculosis reported to CDC; issued revised guidelines cautioning against use of this regimen and only with no preexisting liver disease or alcohol use, with ALT monitoring and provision of drugs in two week increments).
Jasmer RM, Saukkonen JJ, Blumberg HM, Daley CL, Bernardo J, Vittinghoff E, King MD, et al. (2002). Short-Course Rifampin and pyrazinamide for Tuberculosis Infection(SCRIPT) Study Investigators. Short-course rifampin and pyrazinamide compared with isoniazid for latent tuberculosis infection: a multicenter clinical trial. Ann Intern Med. (Controlled trial of isoniazid [INH: 6 months] vs rifampin and pyrazinamide [RP: 2 months] in 589 patients with latent tuberculosis, similar completion rates [57% vs 61%]; ALT rose >5 times ULN in 1% on INH vs 7.7% on RP; none resulted in hospitalization or death; no mention of jaundice).
Ohkawa K, Hashiguchi M, Ohno K, Kiuchi C, Takahashi S, Kondo S, Echizen H, et al. (2002). Risk factors for antituberculous chemotherapy-induced hepatotoxicity in Japanese pediatric patients. Clin Pharmacol Ther. (Retrospective analysis of 99 children who received therapy for tuberculosis, 8 developed hepatotoxicity; risk factors identified were young age and pyrazinamide exposure).
Teleman MD, Chee CB, Earnest A, Wang YT. (2002). Hepatotoxicity of tuberculosis chemotherapy under general programme conditions in Singapore. Int J Tuberc Lung Dis. (Retrospective analysis of 1036 patients treated for active tuberculosis in Singapore during 1998 found 55 cases of liver injury [5.3%], 37 symptomatic [3.6%], 18 jaundiced [1.8%], 3 died [0.3%: all on pyrazinamide]; 48 able to restart therapy; risk factors were age >60 years and baseline liver test abnormalities).
Centers for Disease Control and Prevention (CDC), American Thoracic Society. (2003). Update: adverse event data and revised American Thoracic Society/CDC recommendations against the use of rifampin and pyrazinamide for treatment of latent tuberculosis infection—United States, 2003. MMWR Morb Mortal Wkly Rep. (Fourth alert and issuing of recommendations against use of rifampin/pyrazinamide for latent tuberculosis; with this regimen, estimated rate of ALT elevations >5 times ULN was 2.6%, hospitalization for hepatitis 0.3% and death 0.09%).
American Thoracic Society, Centers for Disease Control and Prevention (CDC). (2003). Infectious Diseases Society of America. Treatment of tuberculosis. MMWR Recomm Rep. (Detailed recommendations on therapy of tuberculosis including drug regimens, side effects, monitoring and optimal approaches to follow up).
Kunimoto D, Warman A, Beckon A, Doering D, Melenka L. (2003). Severe hepatotoxicity associated with rifampin-pyrazinamide preventative therapy requiring transplantation in an individual at low risk for hepatotoxicity. Clin Infect Dis. (37 year old man had AST elevations at end of 2 month course of rifampin/pyrazinamide, with levels rising thereafter to AST 2409 U/L and bilirubin 7.8 mg/dL and need for liver transplant 2 months later).
Nagayama N, Masuda K, Baba M, Tamura A, Nagai H, Akagawa S, Kawabe Y, et al. (2003). Kekkaku. (In Japan there was an apparent increase in rate of ALT elevations reported during isoniazid and rifampin therapy between the years 1980-83 [9%] and 1998-2000 [27%]).
Yee D, Valiquette C, Pelletier M, Parisien I, Rocher I, Menzies D. (2003). Incidence of serious side effects from first-line antituberculosis drugs among patients treated for active tuberculosis. Am J Respir Crit Care Med. (Among 408 adult patients treated for tuberculosis, 37 [9%] had 46 serious adverse events including 12 [3%] instances of hepatitis [ALT >5 times ULN]; risk factors were age [hazard ratio 4.8-7.7], female sex [2.2] and Asian birthplace [2.2]; hepatitis arose in 2% on pyrazinamide and 1% on isoniazid).
Mohan A, Sharma SK. (2004). Side effects of antituberculosis drugs. Am J Respir Crit Care Med. (Letter in response to Yee [2003] requesting further information on doses and clinical features; reply by authors stating that high rate of hepatotoxicity in comparison to reports from India was not due to higher doses of pyrazinamide, but may have been partially due to patient age and diverse ethnic background of patients).
McNeill L, Allen M, Estrada C, Cook P. (2003). Pyrazinamide and rifampin vs isoniazid for the treatment of latent tuberculosis: improved completion rates but more hepatotoxicity. Chest. (Between 1999-2002, 110 patients were treated with pyrazinamide/rifampin [P/R] for 2 months and 114 with isoniazid [INH] for 6 months for latent tuberculosis; completion rates were higher [71% vs 59%] as was hepatotoxicity [13% vs 4%] with PR than INH, and 2 patients had clinically apparent hepatitis [ALT 45-67 times ULN at 4 weeks] but both survived; after intensive monitoring, no further severe cases on P/R).
Stout JE, Engemann JJ, Cheng AC, Fortenberry ER, Hamilton CD. (2003). Safety of 2 months of rifampin and pyrazinamide for treatment of latent tuberculosis. Am J Respir Crit Care Med. (Among 114 patients receiving 2 month course of rifampin/pyrazinamide, 67% completed therapy and 6 had hepatitis [5.3%] but all resolved; no hospitalizations or death).
Fernández-Villar A, Sopeña B, Fernández-Villar J, Vázquez-Gallardo R, Ulloa F, Leiro V, Mosteiro M, et al. (2004). The influence of risk factors on the severity of anti-tuberculosis drug-induced hepatotoxicity. Int J Tuberc Lung Dis. (Among 471 patients receiving antituberculosis therapy, 56 [12%] developed ALT elevations >3 times ULN, 16 [3.4%] and symptoms and 5 [1%] were jaundiced; no deaths. Rates of hepatotoxicity higher in patients with risk factors than without [18.2% vs 5.6%]).
Jasmer RM, Snyder DC, Saukkonen JJ, Hopewell PC, Bernardo J, King MD, Kawamura LM, et al. (2004). Short-course rifampin and pyrazinamide compared with isoniazid for latent tuberculosis infection: a cost-effective analysis based on a multicenter clinical trial. Clin Infect Dis. (Cost effectiveness analysis of two regimens of therapy for latent tuberculosis, suggesting that isoniazid alone for 9 months is less expensive than a short course of rifampin and pyrazinamide and has similar long term efficacy [both regimens increased life expectancy by 1.2 years]).
Ijaz K, McElroy PD, Navin TR. (2004). Short-course rifampin and pyrazinamide compared with isoniazid for latent tuberculosis infection: a cost-effectiveness analysis based on a multicenter clinical trial. Clin Infect Dis. (Letter in response to Jasmer [2004], stressing the recommendation that rifampin and pyrazinamide not be used to treat latent tuberculosis, a 9 month course of isoniazid being safer and more cost effective).
Gordin FM, Cohn DL, Matts JP, Chaisson RE, O'Brien RJ, Terry Beirn Community Programs for Clinical Research on AIDS. (2004). Adult AIDS Clinical Trials Group; Centers for Disease Control and Prevention. Hepatotoxicity of rifampin and pyrazinamide in the treatment of latent tuberculosis infection in HIV-infected persons: is it different than in HIV-uninfected persons?. Clin Infect Dis. (Detailed reanalysis of results of randomized controlled trial comparing 12 months of isoniazid [INH] to 2 months of rifampin/pyrazinamide [R/P] for latent tuberculosis in HIV infected patients; comparing INH to RP recipients, bilirubin >2.5 mg/dL occurred in 0.6% vs 1.8% and AST >250 U/L in 1.6% vs 2.1%, but no hospitalizations or deaths due to hepatotoxicity occurred in the trial; older age was only risk factor identified).
van Hest R, Baars H, Kik S, van Gerven P, Trompenaars MC, Kalisvaart N, Keizer S, et al. (2004). Hepatotoxicity of rifampin-pyrazinamide and isoniazid preventive therapy and tuberculosis treatment. Clin Infect Dis. (Retrospective analysis of patients starting preventive antituberculosis therapy; ALT elevations above 5 times ULN occurred in 8.4% of those receiving 2 months of rifampin/pyrazinamide vs 3.4% of those receiving 6 months of isoniazid).
Marra F, Cox VC, FitzGerald JM, Moadebi S, Elwood RK. (2004). Successful treatment of multidrug-resistant tuberculosis following drug-induced hepatic necrosis requiring liver transplant. Int J Tuberc Lung Dis. (Patient with tuberculous lymphadenitis was treated with isoniazid, rifampin, ethambutol and pyrazinamide and was switched to ciprofloxacin with pyrazinamide and ethambutol when resistance testing was done; four days later she developed fever, rash and fatigue [bilirubin normal, ALT 285 U/L, Alk P normal], but then worsened [bilirubin 15.2 mg/dL, ALT 1165 U/L, Alk P 141 U/L], ultimately requiring liver transplant; she was later treated successfully with levofloxacin, amikacin and streptomycin).
Campos-Franco J, Gonzalez-Quintela A, Alende-Sixto MR. (2004). Isoniazid-induced hyperacute liver failure in a young patient receiving carbamazepine. Eur J Intern Med. (16 year old girl on long term carbamazepine and clobazam with ileocecal tuberculosis developed hepatitis and drowsiness with tremor, 5 days after starting isoniazid, rifampin and pyrazinamide [bilirubin 3.2 mg/dL, ALT 658 U/L, prothrombin index 12%], resolving spontaneously despite continuing anticonvulsants and later tolerating reintroduction of rifampin and pyrazinamide).
Sharma SK. (2004). Antituberculosis drugs and hepatotoxicity. Infect Genet Evol. (Review of hepatotoxicity of isoniazid, rifampin and pyrazinamide with focus on role of acetylator status).
Kandula NR, Dworkin MS, Carroll MR, Lauderdale DS. (2004). Tuberculosis prevention in Mexican immigrants: limitations of short-course therapy. Am J Prev Med. (Among 34 immigrants and contacts of a patient with multidrug resistant tuberculosis treated with rifampin/pyrazinamide, 1 of 11 children [9%] and 4 of 23 adults [17%] developed hepatotoxicity [ALT 165-547 U/L] after 10-53 days; all recovered and were able to finish 4 months of rifampin; points out impracticality of biochemical monitoring in immigrant population).
McElroy PD, Ijaz K, Lambert LA, Jereb JA, Iademarco MF, Castro KG, Navin TR. (2005). National survey to measure rates of liver injury, hospitalization, and death associated with rifampin and pyrazinamide for latent tuberculosis infection. Clin Infect Dis. (Survey of 110 health care programs using the 2 month rifampin/pyrazinamide regimen for latent tuberculosis in 8087 patients between 2000-2; ALT elevations >5 times ULN occurred in 2.4% and hepatitis in 1.9% with 23 hospitalizations and 7 deaths [0.1%] due to acute liver injury; higher than historical rates with isoniazid).
Cook PP. (2006). Rifampin and pyrazinamide for treatment of latent tuberculosis infection. Clin Infect Dis. (Letter in response to McElroy [2005] questioning use of ALT for AST values used to define hepatotoxicity rates; reply by authors suggesting use of “AT” to indicate both enzymes).
Younossian AB, Rochat T, Ketterer JP, Wacker J, Janssens JP. (2005). High hepatotoxicity of pyrazinamide and ethambutol for treatment of latent tuberculosis. Eur Respir J. (Among 12 persons treated with pyrazinamide and ethambutol for latent tuberculosis and contact with a patient with multidrug resistant disease, 7 developed liver injury [ALT 82-1338 U/L], after 87-247 days, 3 with symptoms, no mention of bilirubin levels).
Potolidis E, Mantadakis E, Zeniodi MH, Samonis G. (2005). Rifampin plus pyrazinamide-induced hepatitis requiring hospitalization in a 30-y-old male with latent tuberculosis. Scand J Infect Dis. (30 year old man developed nausea and dehydration 6 weeks after starting rifampin and pyrazinamide for latent tuberculosis [bilirubin normal, ALT “in the range of 600 to 2000” U/L], resolving within 3 weeks of stopping).
Lee BH, Koh WJ, Choi MS, Suh GY, Chung MP, Kim H, Kwon OJ. (2005). Inactive hepatitis B surface antigen carrier state and hepatotoxicity during antituberculosis chemotherapy. Chest. (Retrospective case control study of 110 HBsAg carriers and 97 controls from Korea who received 3-4 drug antituberculosis therapy; any ALT elevations occurred in 34% of carriers vs 20% of controls and were >3 times ULN in 8% vs 4%; no risk factors identified, most tolerated reintroduction of therapy without pyrazinamide).
Lobato MN, Reves RR, Jasmer RM, Grabau JC, Bock NN, Shang N. (2005). 2RZ Study Group. Adverse events and treatment completion for latent tuberculosis in jail inmates and homeless persons. Chest. (Analysis of 2 month course of rifampin and pyrazinamide in jail and homeless populations found ALT elevations >5 times ULN in 6% of patients, one of whom died of acute liver failure, risk factors were older age and baseline ALT levels).
Idilman R, Ersoz S, Coban S, Kumbasar O, Bozkaya H. (2006). Antituberculous therapy-induced fulminant hepatic failure: successful treatment with liver transplantation and nonstandard antituberculous therapy. Liver Transpl. (19 year old woman with peritoneal tuberculosis developed jaundice 4 days after starting isoniazid, rifampin, ethambutol and pyrazinamide [bilirubin 10.5 mg/dL, ALT 1332 U/L, protime 71 sec], undergoing living donor liver transplantation within 2 days and afterwards treated with streptomycin, ethambutol and cycloserine with no recurrence).
Yew WW, Leung CC. (2006). Antituberculosis drugs and hepatotoxicity. Respirology. (Review of incidence, causes, risk factors and management of hepatotoxicity of antituberculosis medications).
Senaratne WV, Pinidiyapathirage MJ, Perera GA, Wickremasinghe AR. (2006). Anti-tuberculosis drug induced hepatitis – a Sri Lankan experience. Ceylon Med J. (Among 783 patients treated for active tuberculosis, 9.5% developed hepatitis; major risk factor being older age).
Cook PP, Maldonado RA, Yarnell CT, Holbert D. (2006). Safety and completion rate of short-course therapy for treatment of latent tuberculosis infection. Clin Infect Dis. (Retrospective analysis of 459 patients treated in public health departments for latent tuberculosis; completion rates were 78% for 2 months of rifampin/pyrazinamide vs 66% for 9 months of isoniazid; any ALT elevations in 18% vs 11%; ALT >5 times ULN in 6% vs 2%; no deaths).
Schechter M, Zajdenverg R, Falco G, Barnes GL, Faulhaber JC, Coberly JS, Moore RD, et al. (2006). Weekly rifapentine/isoniazid or daily rifampin/pyrazinamide for latent tuberculosis in household contacts. Am J Respir Crit Care Med. (In trial comparing rifapentine with isoniazid for 3 months [n=206] vs rifampin and pyrazinamide for 2 months [n=193]; hepatotoxicity arose in 10% on pyrazinamide vs 1% on isoniazid combination, all resolved within two months, no hospitalizations or deaths).
Forget EJ, Menzies D. (2006). Adverse reactions to first-line antituberculosis drugs. Expert Opin Drug Saf. (Review of side effects including hepatotoxicity of isoniazid, rifampin, ethambutol and pyrazinamide; overall rate of hepatotoxicity from pyrazinamide is 1.3-2.5%).
Ijaz K, Jereb JA, Lambert LA, Bower WA, Spradling PR, McElroy PD, Iademarco MF, et al. (2006). Severe or fatal liver injury in 50 patients in the United States taking rifampin and pyrazinamide for latent tuberculosis infection. Clin Infect Dis. (Analysis of 50 cases of severe hepatotoxicity from rifampin/pyrazinamide therapy of latent tuberculosis occurring in US between 1998-2004 and arising during or within 1 month of stopping therapy; fatality rate higher in older patients and with later onset; patients frequently on other potentially hepatotoxic medications).
Shigeto E, Committee for Treatment Japanese Society for Tuberculosis. (2007). Kekkaku. (Abstract: Survey questionnaire to 114 Japanese hospitals identified 70 cases of severe liver injury and 8 deaths due to antituberculosis therapy between 1994-2003).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Population based survey of 126 cases of acute liver injury due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population to be 1300 with use of triple therapy [isoniazid, rifampin and pyrazinamide] and 154 for isoniazid alone, ranking first and third).
Marra F, Marra CA, Bruchet N, Richardson K, Moadebi S, Elwood RK, Fitzgerald JM. (2007). Adverse drug reactions associated with first-line anti-tuberculosis drug regimens. Int J Tuberc Lung Dis. (Among 1061 patients treated for active tuberculosis in British Columbia between 2000-2005 [usually with 3-4 drugs for ~8 months], 148 [14%: 2% per month] developed hepatitis defined by ALT >5 times ULN or symptoms and ALT >3 times ULN]; independent risk factors were pyrazinamide, female sex, older age and baseline ALT levels, but not HBV, HCV or race).
Kwon YS, Koh WJ, Suh GY, Chung MP, Kim H, Kwon OJ. (2007). Hepatitis C virus infection and hepatotoxicity during antituberculosis chemotherapy. Chest. (Retrospective analysis of 54 patients with HCV infection and 97 controls receiving therapy for active tuberculosis; ALT >3 times ULN occurred in 13% of HCV infected vs 4% of controls; none died or required hospitalization).
Huang YS. (2007). Genetic polymorphisms of drug-metabolizing enzymes and the susceptibility to antituberculosis drug-induced liver injury. Expert Opin Drug Metab Toxicol. (Two gene variants have been linked to an increased risk of hepatotoxicity of antituberculosis medications; NAT2 and CYP 2E1, but the associations require further confirmation).
Aouam K, Chaabane A, Loussaïef C, Ben Romdhane F, Boughattas NA, Chakroun M. (2007). Med Mal Infect. (Review of toxicities of antituberculosis agents; pyrazinamide is the most likely agent to cause side effects which can include hepatocellular injury, which is more common with higher doses and arising within the first 2 months of therapy).
Marzuki OA, Fauzi AR, Ayoub S, Kamarul Imran M. (2008). Prevalence and risk factors of anti-tuberculosis drug-induced hepatitis in Malaysia. Singapore Med J. (Among 473 patients treated for tuberculosis, 46 [9.7%] developed ALT elevations >3 times ULN; in a case control analysis, concurrent HIV infection was a risk factor).
Makhlouf HA, Helmy A, Fawzy E, El-Attar M, Rashed HA. (2008). A prospective study of antituberculous drug-induced hepatotoxicity in an area endemic for liver diseases. Hepatol Int. (Among 100 Middle Eastern patients treated for active tuberculosis, 15% had liver toxicity arising in 15-60 days, resolving in 15-45 days of stopping; bilirubin >2 in 5%, 1 death; able to restart therapy in all).
Leiro V, Fernández-Villar A, Valverde D, Constenla L, Vázquez R, Piñeiro L, González-Quintela A. (2008). Influence of glutathione S-transferase M1 and T1 homozygous null mutations on the risk of antituberculosis drug-induced hepatotoxicity in a Caucasian population. Liver International. (Case control study of 35 cases of hepatotoxicity from antituberculosis therapy and 60 controls; found higher rate of T1 GST variants in cases [49%] than controls [27%]; no difference for M1 variants [34% vs 42%]).
Possuelo LG, Castelan JA, de Brito TC, Ribeiro AW, Cafrune PI, Picon PD, Santos AR, et al. (2008). Association of slow N-acetyltransferase 2 profile and anti-TB drug-induced hepatotoxicity in patients from Southern Brazil. Eur J Clin Pharmacol. (Among 17 persons given pyrazinamide and levofloxacin for latent tuberculosis after contact with multidrug resistant tuberculosis, adverse reactions were common, 5 [29%] had ALT elevations [peak 80-504 U/L]; all recovered).
Chang KC, Leung CC, Yew WW, Lau TY, Tam CM. (2008). Hepatotoxicity of pyrazinamide: cohort and case-control analyses. Am J Respir Crit Care Med. (Among 3007 patients starting antituberculosis therapy over a six month period, 150 [5.0%] developed ALT elevations >3 times ULN including 48 that arose after 3 months; in a case control analysis, risk factors were hepatitis B and C and regimens with pyrazinamide).
Vieira DE, Gomes M. (2008). Adverse effects of tuberculosis treatment: experience at an outpatient clinic of a teaching hospital in the city of São Paulo, Brazil. J Bras Pneumol. (Among 297 patients treated for tuberculosis between 2000 and 2006, 24 [10.6%] had hepatotoxicity, 7 [2.4%] symptomatic, no deaths).
Yimer G, Aderaye G, Amogne W, Makonnen E, Aklillu E, Lindquist L, Yamuah L, et al. (2008). Anti-tuberculosis therapy-induced hepatotoxicity among Ethiopian HIV-positive and negative patients. PLoS One. (Between 2004-5, 103 HIV-positive and 94 HIV-negative patients were treated for tuberculosis; subclinical hepatotoxicity occurred in 17% and clinical apparent liver injury with jaundice in 4.1%; risk factors were HIV-positivity and other drug intake, but not age, sex, hepatitis or body mass index).
Sun F, Chen Y, Xiang Y, Zhan S. (2008). Drug-metabolising enzyme polymorphisms and predisposition to anti-tuberculosis drug-induced liver injury: a meta-analysis. Int J Tuberc Lung Dis. (Prospective study in 261 patients treated for tuberculosis; 16% developed hepatitis [ALT or AST > times 5 times ULN or >3 times with symptoms/jaundice], predictive factors were preexisting elevations or low albumin; 49% had at least one ALT or AST elevation, 25% >2 times, 17% >3 times and 10% >5 times ULN).
Kaneko Y, Nagayama N, Kawabe Y, Shimada M, Suzuki J, Kunogi M, Matsui Y, et al. (2008). Kekkaku. (Abstract: there was a substantial increase in frequency of ALT elevations in patients with chronic hepatitis C associated with pyrazinamide therapy).
P V K. (2008). Palaian S, Ojha P, P R S. Pattern of adverse drug reactions experienced by tuberculosis patients in a tertiary care teaching hospital in Western Nepal. Pak J Pharm Sci. (Abstract: Retrospective analysis of 326 Nepalese patients treated for tuberculosis identified 24 [7.4%] with AST elevations; no fatalities from liver disease).
Tostmann A, Boeree MJ, Aarnoutse RE, de Lange WC, van der Ven AJ, Dekhuijzen R. (2008). Antituberculosis drug-induced hepatotoxicity: concise up-to-date review. J Gastroenterol Hepatol. (Review of incidence, pathogenesis, clinical course, risk factors and management of drug induced liver disease due to antituberculosis medications).
Centers for Disease Control and Prevention(CDC). (2009). Trends in tuberculosis—United States, 2008. MMWR Morb Mortal Wkly Rep. (In 2008, 12,898 cases of active tuberculosis in US were reported, lowest rate since reporting began in 1953; incidence rate=3/100,000; 1.2% with multidrug resistant strains).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; isoniazid accounted for 13 cases [4%, ranking 2nd in frequency], pyrazinamide 1, rifampin 1, and isoniazid combined with other agents 2).
Semfke A, Wackernagel C, Vier H, Schütz A, Wiechmann V, Gillissen A. (2009). Histologically proven isoniazid hepatoxicity in complicated tuberculous salpingitis. Ther Adv Respir Dis. (49 year old woman with suspected tuberculous salpingitis developed fever and ALT elevations 1 month after starting isoniazid, rifampin and pyrazinamide, resolved only when she stopped isoniazid, later tolerating rifampin).
Ho CC, Chen YC, Hu FC, Yu CJ, Yang PC, Luh KT. (2009). Safety of fluoroquinolone use in patients with hepatotoxicity induced by anti-tuberculosis regimens. Clin Infect Dis. (Among 1191 patients treated for active tuberculosis, 134 [11%] developed liver injury [risk factors were baseline ALT levels and pyrazinamide use]; then treated with ethambutol with or without streptomycin and randomized to also receive levofloxacin or moxifloxacin, only 1 in each group continued to have ALT elevations and most were then able to restart isoniazid and rifampin).
Walker NF, Kliner M, Turner D, Bhagani S, Cropley I, Hopkins S, Lipman M. (2009). Hepatotoxicity and antituberculosis therapy: time to revise UK guidance?. Thorax. (During a one year period, 14 of 94 patients [15%] with active tuberculosis developed ALT elevations >3 times ULN during therapy; more common in HIV-positive [35%] than -negative [7%]; recommended routine HIV screening and biochemical monitoring in high risk groups).
Tostmann A, van den Boogaard J, Semvua H, Kisonga R, Kibiki GS, Aarnoutse RE, Boeree MJ. (2010). Antituberculosis drug-induced hepatotoxicity is uncommon in Tanzanian hospitalized pulmonary TB patients. Trop Med Int Health. (Among 112 Tanzanian patients with tuberculosis monitored during first 2 months of therapy with isoniazid, rifampin, pyrazinamide and ethambutol, only 7 [6.3%] had ALT elevations [peak level 87 U/L], but none required dose modification).
Sharma SK, Singla R, Sarda P, Mohan A, Makharia G, Jayaswal A, Sreenivas V, et al. (2010). Safety of 3 different reintroduction regimens of antituberculosis drugs after development of antituberculosis treatment-induced hepatotoxicity. Clin Infect Dis. (175 patients with hepatic injury [ALT or AST >5 times ULN or symptoms with ALT elevations] attributed to antituberculosis medications were randomized to 3 different approaches to restarting therapy after initial episode resolved; 11% had recurrence with rates similar for all three regimens [starting agents at full doses or gradual escalation], onset in 5-35 days, none fatal and few with jaundice).
Saukkonen J. (2010). Challenges in reintroducing tuberculosis medications after hepatotoxicity. Clin Infect Dis. (Editorial in response to Sharma [2010], discussing the paradox of why the injury does not recur more often, whether rechallenge should be with one agent at a time, and whether such rechallenge is warranted in patients with severe hepatotoxicity).
Pasipanodya JG, Gumbo T. (2010). Clinical and toxicodynamic evidence that high-dose pyrazinamide is not more hepatotoxic than the low doses currently used. Antimicrob Agents Chemother. (The investigators conducted a systematic review of the literature and metaanalysis; findings indicated lack of association between high dose/exposure and liver toxicity; they concluded that attributable toxicity is idiosyncratic).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 2 antituberculosis agents were among the top 40 cases, including isoniazid [24th, 47 cases], and rifampin [35th, 37 cases]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide and 1 to dapsone).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 181 [58%] were attributed to antituberculosis agents which accounted for 39 of 54 [72%] fatal cases).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, 3 were attributed to isoniazid).
Coca NS, Oliveira MS, Voieta I, Antunes CM, Lambertucci JR. (2010). Antituberculosis drug-induced hepatotoxicity: a comparison between patients with and without human immunodeficiency virus seropositivity. Rev Soc Bras Med Trop. (Using different definitions, rates of hepatotoxicity during antituberculosis therapy were either the same or higher among HIV infected than noninfected subjects).
Ichai P, Saliba F, Antoun F, Azoulay D, Sebagh M, Antonini TM, Escaut L, Delvart V, Castaing D, Samuel D. (2010). Acute liver failure due to antitubercular therapy: Strategy for antitubercular treatment before and after liver transplantation. Liver Transpl. (Description of 14 patients with acute liver failure due to antituberculosis therapy presenting between 1986 and 2008, including 4 men and 10 women, ages 17 to 64 years, on therapy for 1 week to 9 months with isoniazid alone [n=1] or in combination with rifampin, pyrazinamide and ethambutol [bilirubin 1.8 to 39 mg/dL, ALT 214-2020], 7 recovering spontaneously, 6 undergoing liver transplantation, and one dying without transplant).
Baniasadi S, Eftekhari P, Tabarsi P, Fahimi F, Raoufy MR, Masjedi MR, Velayati AA. (2010). Protective effect of N-acetylcysteine on antituberculosis drug-induced hepatotoxicity. Eur J Gastroenterol Hepatol. (Among 60 patients started on antituberculosis therapy using 4 drugs with or without concurrent N-acetylcysteine [NAC: 600 mg twice daily], hepatotoxicity arose in 37% of controls vs 0% of NAC treated subjects, the injury usually arising within the first week and resolving within 8 days of stopping).
Lobue P, Menzies D. (2010). Treatment of latent tuberculosis infection: An update. Respirology. (Extensive review of the efficacy and safety of various regimens used in the treatment of latent tuberculosis).
Leung CC, Rieder HL, Lange C, Yew WW. (2011). Treatment of latent infection with Mycobacterium tuberculosis: update 2010. Eur Respir J. (Review of the efficacy, adherence rates, cost effectiveness and safety of various regimens for the therapy of latent tuberculosis).
Nader LA, de Mattos AA, Picon PD, Bassanesi SL, De Mattos AZ, Pineiro Rodriguez M. (2010). Hepatotoxicity due to rifampicin, isoniazid and pyrazinamide in patients with tuberculosis: is anti-HCV a risk factor?. Ann Hepatol. (Retrospective analysis of 534 patients treated for tuberculosis between 1998 and 2006 found that HIV positivity and high doses of isoniazid were independently associated with a higher risk of hepatotoxicity).
Donald PR. (2011). Antituberculosis drug-induced hepatotoxicity in children. Pediatr Rep. (Extensive review of the literature on hepatotoxicity of antituberculosis medications in children concluded that liver injury occurs in children with isoniazid, pyrazinamide and rifampin, but at a lower rate than in adults).
Thongraung W, Sittidach M, Khwansuwan P, Sariyasuntorn K, Wongsampan S. (2012). Evaluation of the physicians' approach to the diagnosis and treatment of patients with antituberculosis drug-induced hepatotoxicity. J Eval Clin Pract. (Survey of physician practices in Southern Thailand found variability in diagnosis and management of tuberculosis which were not always in compliance with published guidelines).
Perriot J, Chambonnet E, Eschalier A. (2011). Rev Mal Respir. (Review of the side effects of antituberculosis medications).
Devarbhavi H. (2011). Antituberculous drug-induced liver injury: current perspective. Trop Gastroenterol. (Review of hepatotoxicity of antituberculosis medications).
Leiro-Fernandez V, Valverde D, Vázquez-Gallardo R, Botana-Rial M, Constenla L, Agúndez JA, Fernández-Villar A. (2011). N-acetyltransferase 2 polymorphisms and risk of anti-tuberculosis drug-induced hepatotoxicity in Caucasians. Int J Tuberc Lung Dis. (Analysis of N-acetyltransferase 2 polymorphisms in 50 Spanish patients with ALT elevations on antituberculosis therapy and in 67 controls found no difference in acetylation status).
Donald PR. (2011). Antituberculosis drug-induced hepatotoxicity in children. Pediatr Rep. (Review of the hepatotoxicity and antituberculosis medications in children; rates of hepatotoxicity are lower in children than adults, ALT elevations occurring in 10% and jaundice in 0.8% of those receiving antituberculosis therapy and at lower rates with chemo-prophylaxis).
Whitney J, Hurwitz M, Mojtahed A, Hwang C, Gallo A. (2011). Acute liver failure in a pediatric patient with disseminated tuberculosis. Dig Dis Sci. (7 year old boy developed jaundice and mental confusion 2 months after starting therapy with isoniazid, pyrazinamide, rifampin, ethambutol, fluconazole and ceftriaxone [bilirubin 6.5 mg/dL, ALT 396 U/L, GGT 207 U/L, INR 3.6], resolving spontaneously after stopping the regimen and switching to amikacin, cycloserine, ethambutol, levofloxacin and linezolid).
Kim SH, Kim SH, Yoon HJ, Shin DH, Park SS, Kim YS, Park JS, et al. (2012). TNF-α genetic polymorphism -308G/A and antituberculosis drug-induced hepatitis. Liver Int. (Analysis of polymorphisms of TNF alpha in 77 Korean patients who developed ALT elevations >3 times ULN on antituberculosis therapy and 229 who did not , found slightly higher rate of variant allele [-308G/A] associated with hepatotoxicity [26% vs 15%]).
Malla I, Fauda M, Casanueva E, Fernández MI, Amante M, Cheang Y, Giacove G, et al. (2012). Arch Argent Pediatr. (10 year old girl developed jaundice 40 days after starting isoniazid, pyrazinamide and rifampin [bilirubin 13 mg/dL, ALT 37 times ULN, INR 8.5], developing progressive hepatic failure and undergoing successful liver transplantation 2 days after admission).
Cai Y, Yi J, Zhou C, Shen X. (2012). Pharmacogenetic study of drug-metabolising enzyme polymorphisms on the risk of anti-tuberculosis drug-induced liver injury: a meta-analysis. PLoS One. (Metaanalysis of studies of genetic polymorphisms and hepatotoxicity of drugs for tuberculosis identified 38 publications including 2225 patients and 4906 controls; modest association was found between slow NAT2 acetylation genotypes and glutathione-S-transferase genotypes and hepatotoxicity, but largely in Asian populations).
Zhou Y, Yang L, Liao Z, He X, Zhou Y, Guo H. (2013). Epidemiology of drug-induced liver injury in China: a systematic analysis of the Chinese literature including 21,789 patients. Eur J Gastroenterol Hepatol. (Systematic review of the Chinese literature on drug induced liver injury from 1994 to 2011 identified 1119 reports on 21,789 patients; antituberculosis agents were the most commonly implicated drugs [31%]).
Nomi F, Hosaka K, Kurosawa T. (2013). Kekkaku. (Among 321 patients with tuberculosis treated at a single referral hospital during a 5 year period, 7 [2%] developed liver injury with a mixed pattern of enzyme elevations, onset averaging 28 days and resulting in fatality in one).
Kato H, Horita N, Miyazawa N, Yoshiyama T, Ueda A, Ishigatsubo Y. (2013). Risk factors for liver injury with an elevated serum bilirubin concentration caused by antituberculous drugs. Intern Med. (In a retrospective analysis of potential risk factors for liver injury with jaundice due to antituberculosis agents, the level of activity of daily living and concurrent cardiac disease was found to be most strongly associated with occurrence of liver injury).
Miyazawa N, Horita N, Tomaru K, Tsukahara T, Takahashi R, Sasaki M, Ishigatsubo Y. (2013). Kekkaku. (Among 36 Japanese patients with tuberculosis treated with isoniazid, pyrazinamide, rifampin and ethambutol, liver injury occurred in 12.5% over 80 and 14% less than 80 years of age).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 2 [2%] of which were attributed to anti-tuberculosis agents, 1 isoniazid and 1 rifampin).
Gupta VH, Singh M, Amarapurkar DN, Sasi P, Joshi JM, Baijal R. (2013). Association of GST null genotypes with anti-tuberculosis drug induced hepatotoxicity in Western Indian population. Ann Hepatol. (Among 296 patients being treated for tuberculosis, 17% developed ALT elevations during therapy and evidence of liver injury was associated with homozygous null mutations at both glutathione S transferase M1 and T1 gene loci).
Li C, Long J, Hu X, Zhou Y. (2013). GSTM1 and GSTT1 genetic polymorphisms and risk of anti-tuberculosis drug-induced hepatotoxicity: an updated meta-analysis. Eur J Clin Microbiol Infect Dis. (Metaanalysis of studies on the association of tuberculosis drug associated liver injury and polymorphisms of the glutathione S-transferase genes found weak associations only).
Kumar N, Kedarisetty CK, Kumar S, Khillan V, Sarin SK. (2014). Antitubercular therapy in patients with cirrhosis: challenges and options. World J Gastroenterol. (Review of the frequency, pathogenesis and management of hepatotoxicity of antituberculosis therapy in patients with preexisting cirrhosis, who appear to have an increased risk of liver injury from these agents as well as an increased risk of severe outcomes).
Shin HJ, Lee HS, Kim YI, Lim SC, Jung JP, Ko YC, Kwon YS. (2014). Hepatotoxicity of anti-tuberculosis chemotherapy in patients with liver cirrhosis. Int J Tuberc Lung Dis. (Among 50 patients with cirrhosis and 147 controls without cirrhosis who had active tuberculosis and were treated with isoniazid, rifampin ethambutol and pyrazinamide, abnormal liver tests arose in 72% of cirrhotics vs 46% of controls, and predefined "hepatotoxicity" arose in 8% vs 3%, but no patient required hospitalization or died).
Huang YS. (2014). Recent progress in genetic variation and risk of antituberculosis drug-induced liver injury. J Chin Med Assoc. (Critical review of studies on genetic variations associated with antituberculosis drug induced liver injury focusing on N-acetyltransferase (NAT), CYP 2E1, glutathione S transferase and manganese superoxide dismutase, the strongest association being with NAT and slow acetylator status).
Satyaraddi A, Velpandian T, Sharma SK, Vishnubhatla S, Sharma A, Sirohiwal A, Makharia GK, et al. (2014). Correlation of plasma anti-tuberculosis drug levels with subsequent development of hepatotoxicity. Int J Tuberc Lung Dis. (Among 110 patients being treated for tuberculosis, 15 developed evidence of liver injury [enzyme or bilirubin elevations or symptoms]; plasma free rifampin, but not isoniazid or pyrazinamide, levels were higher in patients who developed liver injury than in those who did not).
Xiang Y, Ma L, Wu W, Liu W, Li Y, Zhu X, Wang Q, et al. (2014). The incidence of liver injury in Uyghur patients treated for TB in Xinjiang Uyghur autonomous region, China, and its association with hepatic enzyme polymorphisms nat2, cyp2e1, gstm1 and gstt1. PLoS One. (Among 2244 patients treated for tuberculosis, 89 [4%] had aminotransferase elevations above 2 times and 0.4% above 5 times ULN after 2 months of treatment; evidence of liver injury was more common in persons with NAT2*5*CT genotype, slow acetylator phenotype, but not with CYP 2E1 polymorphisms).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 13 [7%] due to antituberculosis agents including 6 to isoniazid, 1 to pyrazinamide, 1 to rifampin and 5 to combinations).
Li X, Liu Y, Zhang E, He Q, Tang YB. (2015). Liver transplantation in antituberculosis drugs-induced fulminant hepatic failure: a case report and review of the literature. Medicine (Baltimore). (39 year old Chinese woman developed jaundice 3 months after starting isoniazid, rifampin and pyrazinamide for latent tuberculosis [bilirubin 0.6 rising to 41.1 mg/dL, ALT 1414 U/L, Alk P xxx U/L, protime 71 sec], with progressive hepatic failure undergoing liver transplantation 4 months after onset complicated by acute and ultimately fatal chronic rejection).
Jeong I, Park JS, Cho YJ, Yoon HI, Song J, Lee CT, Lee JH. (2015). Drug-induced hepatotoxicity of anti-tuberculosis drugs and their serum levels. J Korean Med Sci. (Among 195 Korean patients with tuberculosis treated with a 4-drug regimen of isoniazid, rifampin, ethambutol and pyrazinamide, drug levels taken within the first week of treatment did not correlate with subsequent rate or severity of antituberculosis drug induced liver injury [n=12: 6%]).
Sharma P, Tyagi P, Singla V, Bansal N, Kumar A, Arora A. (2015). Clinical and biochemical profile of tuberculosis in patients with liver cirrhosis. J Clin Exp Hepatol. (Among 67 patients with cirrhosis treated for tuberculosis with isoniazid, rifampin, ethambutol and either orofloxacin or pyrazinamide, evidence of drug induced liver injury arose in 35% of cases, but none were attributed to ethambutol or pyrazinamide and there were no deaths attributed to drug toxicity).
Horita N, Miyazawa N, Yoshiyama T, Kojima R, Ishigatsubo Y, Kaneko T. (2015). Currently used low-dose pyrazinamide does not increase liver-injury in the first two months of tuberculosis treatment. Intern Med. (Among 383 Chinese patients with tuberculosis treated with isoniazid, rifampin and ethambutol with or without pyrazinamide analyzed in a retrospective study, liver injury arising within the first two months of therapy was less frequent with four drug [8%] than 3-drug regimen [24%]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 54 [6%] were attributed to antituberculosis agents including 48 to isoniazid, 2 to rifampin, 2 [0.2%] to pyrazinamide, 1 to ethambutol and 1 to isoniazid and rifampin).
Bright-Thomas RJ, Gondker AR, Morris J, Ormerod LP. (2016). Drug-related hepatitis in patients treated with standard anti-tuberculosis chemotherapy over a 30-year period. Int J Tuberc Lung Dis. (Among 2070 patients with tuberculosis treated over a 30 year period at a single UK referral center, 63 [3%] developed hepatitis requiring discontinuation of therapy of whom two died; the hepatitis rate was higher in whites than Asians and in females than males, and occurred more commonly with older age; 57% of cases were attributed to pyrazinamide, 32% to rifampin and 11% to isoniazid).
Ji GY, Wang Y, Wu SQ, Liu QQ, Wu JC, Zhang MM, Sandford AJ, et al. (2016). Association between TXNRD1 polymorphisms and anti-tuberculosis drug-induced hepatotoxicity in a prospective study. Genet Mol Res. (Among 248 patients with treated for tuberculosis, 24 [10%] developed evidence of drug induced liver injury, among whom thioredoxin reductase 1 gene variants [involved resistance to oxidative damage] were no different in distribution than among those who did not develop liver injury).
Guaoua S, Ratbi I, El Bouazzi O, Hammi S, Tebaa A, Bourkadi JE, Bencheikh RS, et al. (2016). NAT2 genotypes in Moroccan patients with hepatotoxicity due to antituberculosis drugs. Genet Test Mol Biomarkers. (Among 42 Moroccan patients with liver injury during antituberculosis therapy, there were no differences in frequency of acetylator status or in NAT2 genotypes compared to controls).
Wang FJ, Wang Y, Niu T, Lu WX, Sandford AJ, He JQ. (2016). Update meta-analysis of the CYP2E1 RsaI/PstI and DraI polymorphisms and risk of antituberculosis drug-induced hepatotoxicity: evidence from 26 studies. J Clin Pharm Ther. (Metaanalysis of 26 studies involving 7423 patients found that the CYP2E1 RsaI/PstI c1/c1 polymorphism was associated with an increased risk for liver injury caused by antituberculosis therapy with an odds ratio of 1.32).
Lin HS, Cheng CW, Lin MS, Chou YL, Chang PJ, Lin JC, Ye JJ. (2016). The clinical outcomes of oldest old patients with tuberculosis treated by regimens containing rifampicin, isoniazid, and pyrazinamide. Clin Interv Aging. (Among 700 Taiwanese patients with active tuberculosis treated with isoniazid, rifampin and pyrazinamide, hepatitis arose in 83 [12%] and was more frequent in those above the age of 80 years [17.4%] compared to younger [10.2%], but details on severity and clinical features were not provided).
Chen G, Wu SQ, Feng M, Wang Y, Wu JC, Ji GY, Zhang MM, et al. (2017). Association of UGT2B7 polymorphisms with risk of induced liver injury by anti-tuberculosis drugs in Chinese Han. Int J Immunopathol Pharmacol. (Among 247 Chinese patients who received antituberculosis therapy for at least 3 months, 24 [10%] developed evidence of hepatic injury, but there was no association with polymorphisms of UGT2B7 a major hepatic enzyme responsible for glucuronidation and excretion of drugs and xenobiotics).
Zenner D, Beer N, Harris RJ, Lipman MC, Stagg HR, van der Werf MJ. (2017). Treatment of latent tuberculosis infection: an updated network meta-analysis. Ann Intern Med. (A metaanalysis of 61 studies on regimens for therapy of "latent tuberculosis" found evidence of lower rates of hepatotoxicity with rifampin only or short courses of isoniazid and rifampin compared to longer isoniazid only regimens).
Wang Y, Xiang X, Wu SQ, Chen G, Zhang MM, Wang MG, Wang FJ, et al. (2017). Association of CYP2B6 gene polymorphisms and anti-tuberculosis drug-induced hepatotoxicity in a Chinese population. Infect Genet Evol. (Among 343 Chinese patients treated for tuberculosis, several CYP2B6 gene polymorphisms were found to be associated with a reduced risk for hepatotoxicity).
Angamo MT, Chalmers L, Curtain CM, Yilma D, Bereznicki L. (2018). Mortality from adverse drug reaction-related hospitalizations in south-west Ethiopia: A cross-sectional study. J Clin Pharm Ther. (Among 1001 patients admitted to an Ethiopian hospital over a 1 year period, 103 were admitted for an adverse drug reaction, 15 of which were fatal, with 7 due to liver failure, implicated agents being isoniazid, pyrazinamide, efavirenz and tenofovir).
Lee LN, Huang CT, Hsu CL, Chang HC, Jan IS, Liu JL, Sheu JC, et al. (2019). Mitochondrial DNA variants in patients with liver injury due to anti-tuberculosis drugs. J Clin Med. (Among 38 patients who developed liver injury during antituberculosis therapy, sequencing of mitochondrial DNA identified a higher frequency of point mutations in complex I NADH subunits 1 and 5 in isoniazid cases [n=8] but not in pyrazinamide [n=14] or rifampin [n=16] associated cases).
Hagiwara E, Suido Y, Asaoka M, Katano T, Okuda R, Sekine A, Kitamura H, et al. (2019). Safety of pyrazinamide-including regimen in late elderly patients with pulmonary tuberculosis: A prospective randomized open-label study. J Infect Chemother. (Among 89 elderly patients [80 years or older] with tuberculosis treated with isoniazid, rifampin and ethambutol with or without pyrazinamide, rates of discontinuation were similar between the two groups [33% vs 35%] as well as rates of ALT or AST elevations above 2.5 times ULN [18% vs 23%]).
Wang Y, Xiang X, Huang WW, Sandford AJ, Wu SQ, Zhang MM, Wang MG, et al. (2019). Association of PXR and CAR polymorphisms and antituberculosis drug-induced hepatotoxicity. Sci Rep. (Among 502 patients with tuberculosis treated with isoniazid, rifampin, ethambutol and pyrazinamide 19% developed ALT elevations above 10 times ULN, several polymorphisms of PXR [but not CAR] were associated with a lower incidence of liver injury).
Dheda K, Gumbo T, Maartens G, Dooley KE, Murray M, Furin J, Nardell EA, Warren RM. (2019). Lancet Respiratory Medicine drug-resistant tuberculosis Commission group. The Lancet Respiratory Medicine Commission: 2019 update: epidemiology, pathogenesis, transmission, diagnosis, and management of multidrug-resistant and incurable tuberculosis. Lancet Respir Med. (Review of the epidemiology, pathogenesis, diagnosis and management of multidrug resistant tuberculosis; does not discuss hepatotoxicity of therapeutic drug regimens).
Oscanoa T, Moscol S, Amado J. (2020). Clinical characteristics of pyrazinamide-associated hepatotoxicity in patients at a hospital in Lima, Peru. Rev Peru Med Exp Salud Publica. (Among 10 patients with suspected pyrazinamide hepatotoxicity, the average age was 41 years and average time to onset 41 days [range 11 to 130 days], 20% with rash and 40% with jaundice, hepatocellular enzyme elevations in 5, resolving in all patients).
Zhao H, Wang Y, Zhang T, Wang Q, Xie W. (2020). Drug-induced liver injury from anti-tuberculosis treatment: a retrospective cohort study. Med Sci Monit. (Among 140 patients with liver injury due to antituberculosis therapy seen between 2009 and 2015, the median age was 40, time to onset ranged from 7-90 days [mean=24], 35% had fever, 16% rash, 68% were hepatocellular, 21% were severe and 7% died; most patients had received isoniazid, rifampin and pyrazinamide).
Soni H, Kumar-M P, Mishra S, Bellam BL, Singh H, Mandavdhare HS, Medhi B, et al. (2020). Risk of hepatitis with various reintroduction regimens of anti-tubercular therapy: a systematic review and network meta-analysis. Expert Rev Anti Infect Ther. (Systematic review of the risk of recurrence of hepatotoxicity on reintroduction of antituberculosis agents after occurrence of drug induced liver injury indicated that sequential and incremental introduction is preferable to rechallenge with both agents concurrently).
CDC. https://www.cdc.gov/tb/ (CDC website with up-to-date recommendations on therapy of tuberculosis).

## OTHER REFERENCE LINKS

1 Recent References on Pyrazinamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pyrazinamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pyrazinamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pyrazinamide)